# Tenofovir

## OVERVIEW

### Introduction

Tenofovir is an acyclic nucleotide analogue of adenosine used in combination with other agents in the therapy of the human immunodeficiency virus (HIV) and as single agent in hepatitis B virus (HBV) infection. Tenofovir does not appear to be a significant cause of drug induced liver injury.

### Background

Tenofovir (ten of' oh vir) is an acyclic nucleotide analogue of adenosine, but is poorly absorbed orally. For this reason, the prodrug is used, either tenofovir disoproxil fumarate or more recently tenofovir alafenamide, which are well absorbed from the intestines, rapidly hydrolyzed to tenofovir intracellularly and then phosphorylated to the active form, tenofovir diphosphate. Tenofovir diphosphate is a competitive inhibitor of the HIV reverse transcriptase (and the HBV polymerase) and is also incorporated into the nascent DNA strand causing chain termination. Tenofovir disoproxil fumarate (TDF) was approved for use in HIV infection in the United States in 2001 and for use in hepatitis B in 2008. Tenofovir alafenamide (TAF) was approved in 2015 for use both in HIV and HBV infection. Clinical indications include treatment and prevention of HIV infection, usually in combination with other reverse transcriptase, protease or integrase inhibitors. Tenofovir is also approved for use in chronic hepatitis B as a single agent. TDF is available generically and under the brand name Viread in 300 mg oral tablets. TAF is available under the brand name Vemlidy in 25 mg tablets. Both TDF and TAF are also available in various fixed combinations with other antiviral agents for use in treatment of HIV infection, usually in a single oral daily dose that is often referred to as a “single tablet regimen” (STR) which is extremely helpful in insuring compliance with HIV therapy. Examples of some of the single tablet regimen combinations and their brand names and doses are given in the Table below. The recommended daily dose of TDF in adults is 300 mg and of TAF is 25 mg, the lower dose of TAF being considered important in decreasing long term side effects, particularly those on phosphate metabolism and bone and kidney effects. Side effects of tenofovir are not common but can include asthenia, diarrhea, flatulence, nausea and vomiting, headache, renal dysfunction and rash. Rare but potentially severe adverse events associated with long term therapy include lactic acidosis and liver failure when given with other antiretroviral agents, severe withdrawal flares of hepatitis B upon discontinuation of tenofovir therapy, osteoporosis, and phosphate wasting proximal tubular dysfunction, renal tubular acidosis and renal failure. The bone and renal effects of tenofovir are believed to be less common with TAF than TDF.

Table: Tenofovir Combination Single Tablet Regimens Approved for HIV Therapy*^†^

Brand Name | # | Drug #1 | Drug #2 | Drug #3 | Drug #4
Atripla | 3 | TDF 300 | Emtricitabine 200 | Efavirenz 600
Biktarvy | 3 | TAF 25 | Emtricitabine 200 | Bictegravir 50
Cimduo | 2 | TDF 300 | Lamivudine 300
Complera | 3 | TDF 300 | Emtricitabine 200 | Rilpivirine 25
Delstrigo | 3 | TDF 300 | Lamivudine 300 | Doravirine 100
Descovy | 2 | TAF 25 | Emtricitabine 200
Genvoya | 4 | TAF 10 | Emtricitabine 200 | Elvitegravir 25 | Cobicistat 150
Odefsey | 3 | TAF 25 | Emtricitabine 200 | Rilpivirine 25
Stribild | 4 | TDF 300 | Emtricitabine 200 | Elvitegravir 25 | Cobicistat 150
Symfi | 3 | TDF 300 | Lamivudine 300 | Efavirenz 600
Symfi Lo | 3 | TDF 300 | Lamivudine 300 | Efavirenz 400
Symtuza | 4 | TAF 10 | Emtricitabine 200 | Darunavir 800 | Cobicistat 150
Temixys | 2 | TDF 300 | Lamivudine 300
Truvada | 2 | TDF 300 | Emtricitabine 200

Abbreviations: TDF, tenofovir disoproxil fumarate; TAF, tenofovir alafenamide.

* Dose given after each agent in mg/day.

^†^ The 2 drug regimens are tenofovir [TDF or TAF] with a nucleoside reverse transcriptase inhibitor; the 3 drug regimens add a nonnucleoside reverse transcriptase inhibitor, or an HIV protease inhibitor or an HIV integrase inhibitor to the 2 drug regimens; the 4 drug regimens add a CYP 3A4 inhibitor as a pharmacological enhancer.

### Hepatotoxicity

Like all nucleoside analogues used as therapy of hepatitis B, tenofovir can cause transient increases in serum aminotransferases during or after therapy. These abnormalities appear to be due to an exacerbation or flare of the underlying hepatitis B. Three types of flares due to nucleoside analogue therapy have been described: transient flares during initiation of therapy (treatment flares), flares occurring in association with development of antiviral resistance (breakthrough flares) and flares occurring in the few months after stopping therapy (withdrawal flares). Treatment flares generally arise during the first few months of starting therapy, are usually mild, asymptomatic and self-limited and do not require dose modification or interruption of therapy. Breakthrough flares generally follow the development of antiviral resistance and subsequent rise in HBV DNA levels during nucleoside analogue therapy. Breakthrough flares can be symptomatic and severe. Because tenofovir is associated with a very low rate of antiviral resistance (<1% after 4 years), no convincing cases of breakthrough hepatitis have been linked to its use. Finally, sudden discontinuation of antiviral therapy is capable of causing a hepatitis B withdrawal flare. Withdrawal flares can be severe and several instances of acute liver failure resulting in death or the need for liver transplantation have been reported after stopping nucleoside analogue therapy. The rate of such flares after withdrawal of tenofovir therapy has not been clearly defined.

Tenofovir appears to have little or no direct hepatotoxicity. In patients without HBV and HIV infection, given tenofovir as a part of preexposure prevention, minor serum ALT and AST elevations are more frequent than with placebo, but are rarely above 5 times ULN (<1%). There have been no convincing reports of acute, clinically apparent liver injury attributable to tenofovir, although the combination of tenofovir and didanosine appears to lead to liver injury, with microvesicular fatty liver disease and lactic acidosis more commonly than didanosine with other antiretrovirals, perhaps because of drug-drug interactions. Tenofovir may also predispose to serum aminotransferase elevations during efavirenz therapy, again possibly because of drug-drug interactions.

Likelihood score: C (has been associated with flares of hepatitis when it is withdrawn and rarely with a sudden antiviral effect early during therapy and finally linked to episodes of lactic acidosis due to its effects on drug levels of other nucleosides that can cause lactic acidosis).

### Mechanism of Injury

The majority of cases of lactic acidosis and hepatic failure in patients receiving tenofovir appear to be due to didanosine, stavudine or zidovudine coadministration. Addition of tenofovir to an antiretroviral regimen including didanosine concurrently can increase didanosine concentrations by up to 60%, thus amplifying its potential to cause mitochondrial injury. Tenofovir by itself appears to have little hepatotoxic potential.

### Outcome and Management

The minor ALT elevations associated with initiation of tenofovir therapy in chronic hepatitis B are usually asymptomatic and transient. Care should be taken in stopping tenofovir therapy in patients with chronic HBV infection. If administered concurrently with tenofovir, didanosine should be reduced in dosage and patients monitored carefully.

Agents used in therapy of HBV infection include adefovir, emtricitabine, entecavir, lamivudine, telbivudine, tenofovir, interferon alfa and peginterferon.

Drug Class: Antiviral Agents, Antiretroviral Agents, Hepatitis B Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Adefovir, Didanosine, Emtricitabine, Entecavir, Lamivudine, Stavudine, Telbivudine, Zidovudine

## CASE REPORTS

### Case 1. Lactic acidosis arising during therapy with didanosine after addition of tenofovir.(1)

A 45 year old woman with HIV infection and chronic hepatitis C developed vomiting, abdominal pain, and obtundation 8 weeks after the addition of tenofovir to her long term antiretroviral regimen of stavudine and didanosine. Tenofovir was used to replace nevirapine, which was discontinued because of minor serum enzymes elevations which then returned to initial values. On admission, she was jaundiced and disoriented and had tender hepatomegaly. Serum bilirubin was 12.6 mg/dL, ALT 157 U/L, and an international normalized ratio (INR) was 2.1. She had lactic acidosis with blood pH of 7.24 and lactate levels of 16.4 mmol/L. Imaging of the liver suggested fatty infiltration. Antiretrovirals were discontinued, but the lactic acidosis and hepatic failure worsened and she died two days after admission.

#### Key Points

Medication: | Didanosine, stavudine, and tenofovir
Pattern: | Mild serum ALT elevations
Severity: | 5 (fatal)
Latency: | 8 weeks
Recovery: | None
Other medications: | Nevirapine, 8 weeks previously

#### Comment

Acute microvesicular hepatic steatosis with liver failure and lactic acidosis is a syndrome associated with several medications including the nucleoside analogues, particularly didanosine, stavudine and zidovudine. A similar syndrome occurs with intravenous tetracycline, aspirin (Reyes syndrome) and valproate, but the timing and course is different for those agents (shorter latency period), probably because they directly affect function of mitochondria rather than by causing functional failure by inhibition of mitochondrial replication and mitochondrial depletion. Mitochondria have a half-life of several weeks, so that inhibition of mitochondrial replication would be expected to lead to severe dysfunction (mitochondrial failure) after 2 to 3 months. Both didanosine and stavudine have been linked to many cases of hepatic steatosis and lactic acidosis and the addition of tenofovir appears to increase the risk of this complication. This syndrome has not been reported with the use of tenofovir alone. Other risk factors for hepatic steatosis with lactic acidosis include presence of underlying liver disease (such as hepatitis C), obesity and alcohol use.

### Case 2. Transient flare of hepatitis B with initiation of tenofovir therapy.(2)

A 29 year old Asian-American woman was started on the combination of tenofovir and emtricitabine (Truvada) in a clinical trial of therapy of HBeAg-positive hepatitis B and developed a doubling of serum ALT levels to ~14 times the upper limit of normal within two weeks of starting therapy. At the same time, HBV DNA levels had fallen by four log10 IU (352 million to 36,160 IU/mL), but she remained HBsAg and HBeAg positive. Serum direct and total bilirubin levels increased slightly, but remained in the normal range. She had no symptoms of hepatitis and reported no other side effects. Tests for hepatitis A, C and D showed no evidence of de novo infection with these viruses. She was taking no other medications or herbal products. The dose of tenofovir and emtricitabine was not changed and, subsequently, her serum aminotransferase levels fell into the normal range and HBV DNA to undetectable. After 36 weeks of treatment, she became HBeAg-negative but did not develop anti-HBe. At one year, histologic evidence of inflammation and fibrosis had improved, but she remained HBsAg-positive and was continued on therapy.

#### Key Points

Medication: | Tenofovir (300 mg) and emtricitabine (200 mg) daily
Pattern: | Hepatocellular (ALT elevations only; R=14)
Severity: | 1+ (aminotransferase elevations without jaundice)
Latency: | 1 month
Recovery: | 2 weeks
Other medications: | None

#### Laboratory Values

Weeks After Starting | ALT (U/L) | Alk P (U/L) | Direct and Total Bilirubin (mg/dL) | | HBV DNA (IU/mL) | Other
Pre | 261 | 67 | 0.2 | 0.8 | 76,000,000
0 | 272 | 69 | 0.2 | 0.6 | 352,000,000 | HBeAg +ve
2 | 569 | 95 | 0.3 | 1.0 | 36,100 | INR=1.06
4 | 26 | 59 | 0.1 | 0.7 | 91
8 | 30 | 45 | 0.0 | 0.7 | 28
12 | 43 | 43 | 0.1 | 0.5 | <10
24 | 23 | 52 | 0.2 | 0.6 | <10
36 | 23 | 82 | 0.1 | 0.5 | <10 | HBeAg -ve
48 | 22 | 62 | 0.2 | 0.6 | <10
Normal | <40 | <115 | <0.3 | <1.2 | <10

#### Comment

A minor flare in hepatitis is not uncommon with initiation of antiviral therapy of hepatitis B and should not lead to dose modification, if HBV DNA levels are decreasing and no other cause for acute liver injury can be found. The flare of hepatitis probably represents an immunological reaction to the sudden decrease in HBV replication and may actually be a favorable sign, predictive of a serological and virological response (loss of HBeAg during treatment which occurred at 36 weeks).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tenofovir (Tenofovir disoproxil fumarate) – Generic, Viread®

Tenofovir (Tenofovir alafenamide) – Generic, Vemlidy®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tenofovir%20disoproxil%20fumarate) (Tenofovir disoproxil fumarate)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tenofovir%20alafenamide) (Tenofovir alafenamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tenofovir | 147127-20-6 | C9-H14-N5-O4-P

## CITED REFERENCES

1 Rivas P, Polo J, de Górgolas M, Fernández-Guerrero ML. (2003). Drug Points: Fatal lactic acidosis associated with tenofovir. BMJ.
2 Case from the National Institutes of Health, Tenofovir Study Patient A2.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2020

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
NIH. http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Brinkman K, ter Hofstede HJ, Burger DM, Smeitink JAM, Koopmans PP. (1998). Adverse effects of reverse transcriptase inhibitors: mitochondrial toxicity as a common pathway. AIDS. (Review of mitochondrial function and role of mitochondrial toxicity or depletion in the adverse side effects of nucleoside analogues).
Gallant JE, Deresinski S. (2003). Tenofovir disoproxil fumarate. Clin Infect Dis. (Review on the efficacy and safety of tenofovir mentions that it is well tolerated and has little evidence of mitochondrial toxicity).
Cihlar T, Birkus G, Greenwalt DE, Hitchcock MJM. (2002). Tenofovir exhibits low cytotoxicity in various human cell types: comparison with other nucleotide reverse transcriptase inhibitors. Antiviral Research. (In vitro study of nucleoside analogues found that tenofovir and lamivudine were less cytotoxic to several human cell types than zidovudine, stavudine, didanosine or zalcitabine).
Clark SJ, Creighton S, Portmann B, Taylor C, Wendon JA, Cramp ME. (2002). Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol. (6 HIV-positive patients were admitted with acute liver failure over a 25 month period, of whom five died; all had been treated with antiretrovirals and only two had had AIDS-defining illnesses).
Pecora Fulco P, Kirian MA. (2003). Effect of tenofovir on didanosine absorption in patients with HIV. Ann Pharmacother. (When given together, tenofovir increases plasma concentrations of didanosine).
Blanchard JN, Wohlfeiler M, Canas A, King K, Lonergan JT. (2003). Pancreatitis with didanosine and tenofovir disoproxil fumarate. Clin Infect Dis. (4 patients developed pancreatitis and lactic acidosis arising 2-6 months after adding tenofovir to HIV regimen including didanosine; 1 died, 3 who survived were able to restart tenofovir without didanosine; liver tests mentioned only in fatal case [bilirubin 5.3 mg/dL, ALT 89 U/L]).
Callens S, De Schacht C, Huyst V, Colebunders R. (2003). Pancreatitis in an HIV-infected person on a tenofovir, didanosine and stavudine containing highly active antiretroviral treatment. J Infect. (33 year old woman developed pancreatitis 5 months after starting didanosine and 1 month after addition of tenofovir to HIV regimen [ALT 386 U/L, Alk P 208 UL, amylase 11395 U/L], resolving rapidly when antivirals were stopped).
Rivas P, Polo J, de Górgolas M, Fernández-Guerrero ML. (2003). Drug Points: Fatal lactic acidosis associated with tenofovir. BMJ. (45 year old woman with HIV infection treated with didanosine and stavudine developed jaundice and hepatomegaly 8 weeks after switching from nevirapine to tenofovir [bilirubin 12.6 mg/dL, ALT 157 U/L, CT showed fatty liver], despite stopping antivirals and medical support lactic acidosis worsened and she died 36 hours later: Case 1).
Murphy MD, O’Hearn M, Chou S. (2003). Fatal lactic acidosis and acute renal failure after addition of tenofovir to an antiretroviral regimen containing didanosine. Clin Infect Dis. (49 year old man with HIV infection and renal insufficiency on long term didanosine developed progressive, fatal lactic acidosis 6 weeks after starting tenofovir [lactate 5.5 rising to 16.7 mmol]; no mention of liver injury).
Gallant JE, Staszewski S, Pozniak AL, DeJesus E, Suleiman JM, Miller MD, Coakley DF, et al. (2004). 903 Study Group. Efficacy and safety of tenofovir DF vs stavudine in combination therapy in antiretroviral-naïve patients: a 3-year randomized trial. JAMA. (Controlled trial of 3 years of tenofovir vs stavudine added to lamivudine and efavirenz in 600 treatment-naïve patients with HIV; ALT rises above 5 times normal occurred in 4% of tenofovir- vs 5% of stavudine-treated; lactic acidosis arose in no tenofovir- vs 3 [1%] stavudine-treated subjects).
Guo Y, Fung HB. (2004). Fatal lactic acidosis associated with coadministration of didanosine and tenofovir disoproxil fumarate. Pharmacotherapy. (63 year old man with HIV-HCV coinfection developed fatal lactic acidosis 1.5 years after starting didanosine-tenofovir-lopinavir-ritonavir regimen with pancreatitis, multiorgan failure and death; liver injury not mentioned).
Giola M, Basilico C, Grossi P. (2005). Fatal lactic acidosis associated with tenofovir and abacavir. Int J Infect Dis. (60 year old man with HIV infection developed fatal lactic acidosis and aminotransferase elevations 5 months after being switched from stavudine to abacavir while continuing tenofovir and nevirapine [ALT 70 U/L, lactate 9.7 mmol], and progressive acidosis).
Abrescia N, D’Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. (2005). Hepatotoxicity of antiretroviral drugs. Curr Pharm Des. (Review of risk factors, epidemiology and pathogenic mechanisms of hepatotoxicity caused by antiretroviral drugs).
Masiá M, Gutiérrez F, Padilla S, Ramos JM, Pascual J. (2005). Severe toxicity associated with the combination of tenofovir and didanosine: case report and review. Int J STD AIDS. (45 year old man with HIV-HCV coinfection developed lactic acidosis and “mild cholestasis” 3 months after adding tenofovir to didanosine, resolving slowly after stopping therapy).
Pozniak AL, Gallant JE, DeJesus E, Arribas JR, Gazzard B, Campo RE, Chen SS, et al. (2006). Tenofovir disoproxil fumarate, emtricitabine, and efavirenz versus fixed-dose zidovudine/lamivudine and efavirenz in antiretroviral-naive patients: virologic, immunologic, and morphologic changes—a 96-week analysis. J Acquir Immune Defic Syndr. (Controlled trial of tenofovir and emtricitabine vs zidovudine and lamivudine combined with efavirenz in 517 patients with HIV infection; elevations in ALT >3 times normal occurred in 8% vs 9% in first 2 years of study).
Jain MK. (2007). Drug-induced liver injury associated with HIV medications. Clin Liver Dis. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], and cholestatic hepatitis [many agents]).
Lapadula G, Izzo I, Costarelli S, Cologni G, Bercich L, Casari S, Gambarotti M, et al. (2007). Dideoxynucleoside HIV reverse transcriptase inhibitors and drug-related hepatotoxicity: a case report. J Med Case Rep. (43 year old with HIV infection on stavudine for 3 years and tenofovir for 6 months developed rise in ALT levels (222 to 392 U/L), which persisted despite stopping indinavir and resolved slowly after stopping stavudine; liver biopsy showed inflammation, fat and Mallory bodies).
Lattuada E, Lanzafame M, Carolo G, Gottardi M, Concia E, Vento S. (2008). Does tenofovir increase efavirenz hepatotoxicity?. AIDS. (Three patients with HIV infection without hepatitis B or C on efavirenz therapy developed ALT elevations 4-6 weeks after starting tenofovir [ALT 144, 186 and 392 U/L] [previously normal], resolving with stopping tenofovir).
Marcellin P, Heathcote EJ, Buti M, Gane E, de Man RA, Krastev Z, Germanidis G, et al. (2008). Tenofovir disoproxil fumarate versus adefovir dipivoxil for chronic hepatitis B. N Engl J Med. (Two controlled trials of tenofovir vs adefovir in 641 patients with chronic hepatitis B; ALT levels above 5 times the ULN occurred in 6% of tenofovir vs 3% of adefovir recipients, usually within 8 weeks of starting; all self-limited even with continuing drug).
Hammer SM, Eron JJ, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al., International AIDS Society-USA. (2008). Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA. (Recent recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents raltegravir, maraviroc and etravirine).
Inductivo-Yu I, Bonacini M. (2008). Highly active antiretroviral therapy-induced liver injury. Current Drug Safety. (Review of drug induced liver injury due to antiretroviral agents).
Soriano V, Puoti M, Garcia-Gascó P, Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. (2008). Antiretroviral drugs and liver injury. AIDS. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes: problematic agents include didanosine, stavudine and zidovudine, nevirapine and efavirenz, full dose ritonavir and tipranavir).
Nüesch R, Ananworanich J, Srasuebkul P, Chetchotisakd P, Prasithsirikul W, Klinbuayam W, Mahanontharit A, et al. (2008). Interruptions of tenofovir/emtricitabine-based antiretroviral therapy in patients with HIV/hepatitis B virus co-infection. AIDS. (Among 10 patients with HIV-HBV coinfection on tenofovir therapy, 6 had a rise in HBV DNA levels and one had a clinically significant flare of hepatitis within 6 months of tenofovir withdrawal; all responded to restarting).
Sulkowski MS. (2008). Management of hepatic complications in HIV-infected persons. J Infect Dis. (Review of the complications, natural history and management of hepatitis B in patients with HIV infection).
Fontana RJ. (2009). Side effects of long-term oral antiviral therapy for hepatitis B. Hepatology. (Review of side effects of nucleoside analogues used to treat chronic hepatitis B).
Ortu F, Weimer LE, Floridia M, Manconi PE. (2010). Raltegravir, tenofovir, and emtricitabine in an HIV-infected patient with HCV chronic hepatitis, NNRTI intolerance and protease inhibitors-induced severe liver toxicity. Eur J Med Res. (43 year old woman with HIV/HCV coinfection developed symptomatic elevations of serum enzymes on saquinavir, fosamprenavir and again on darunavir, was adequately maintained on tenofovir/emtricitabine and raltegravir).
Garg H, Sarin SK, Kumar M, Garg V, Sharma BC, Kumar A. (2011). Tenofovir improves the outcome in patients with spontaneous reactivation of hepatitis B presenting as acute-on-chronic liver failure. Hepatology. (Randomized trial of tenofovir versus placebo in 90 patients with acute liver failure due to spontaneous reactivation of hepatitis B found improved survival at 3 months with tenofovir therapy and no evidence of renal or liver toxicity from the antiviral).
Dore GJ, Soriano V, Rockstroh J, Kupfer B, Tedaldi E, Peters L, Neuhaus J, et al., SMART INSIGHT study group. (2010). Frequent hepatitis B virus rebound among HIV-hepatitis B virus-coinfected patients following antiretroviral therapy interruption. AIDS. (Among 54 patients with HIV-HBV coinfection who were withdrawn from chronic antiretroviral therapy, 12 [22%] had a >3 log rebound in HBV DNA levels including 7 of 17 [41%] who had been on tenofovir vs 3 of 27 [11%] on lamivudine; ALT flares were uncommon and no patient developed hepatic decompensation).
DeJesus E, Rockstroh JK, Henry K, Molina JM, Gathe J, Ramanathan S, Wei X, et al. (2012). GS-236-0103 Study Team. Co-formulated elvitegravir, cobicistat, emtricitabine, and tenofovir disoproxil fumarate versus ritonavir-boosted atazanavir plus co-formulated emtricitabine and tenofovir disoproxil fumarate for initial treatment of HIV-1 infection: a randomised, double-blind, phase 3, non-inferiority trial. Lancet. (Controlled trial of two combination regimens of once daily antiviral agents in 708 patients with HIV infection for at least 48 weeks; ALT elevations occurred in 18% vs 22% and bilirubin elevations in 11% vs 96% of patients in the tenofovir/emtricitabine/elvitegravir/cobicistat vs the atazanavir/ritonavir/tenofovir/ emtricitabine combination, the ALT elevations being attributable to underlying liver disease in most cases and the bilirubin elevations largely due to atazanavir).
Vermund SH. (2013). Safety and tolerability of tenofovir for preexposure prophylaxis among men who have sex with men. J Acquir Immune Defic Syndr. (Editorial in response to Grohskopf et al [2013]).
Grohskopf LA, Chillag KL, Gvetadze R, Liu AY, Thompson M, Mayer KH, Collins BM, et al. (2013). Randomized trial of clinical safety of daily oral tenofovir disoproxil fumarate among HIV-uninfected men who have sex with men in the United States. J Acquir Immune Defic Syndr. (Controlled trial of daily oral tenofovir vs placebo for 24 months in 373 HIV negative men who have sex with men found no excess of adverse events in tenofovir- vs placebo-treated subjects and no hepatic severe adverse events; changes in ALT levels were not discussed).
Marcellin P, Gane E, Buti M, Afdhal N, Sievert W, Jacobson IM, Washington MK, et al. (2013). Regression of cirrhosis during treatment with tenofovir disoproxil fumarate for chronic hepatitis B: a 5-year open-label follow-up study. Lancet. (Among 348 patients with chronic hepatitis B who underwent liver biopsy before and after a 4 year course of tenofovir, liver histology improved in 304 [87%] and fibrosis regressed in 176 [51%], including 74% of those who had cirrhosis on initial biopsy; no antiviral resistance breakthroughs occurred).
Köklü S, Tuna Y, Gülşen MT, Demir M, Köksal AŞ, Koçkar MC, Aygün C, et al. (2013). Long-term efficacy and safety of lamivudine, entecavir, and tenofovir for treatment of hepatitis B virus-related cirrhosis. Clin Gastroenterol Hepatol. (Retrospective analysis of 227 patients with cirrhosis due to hepatitis B who were treated with lamivudine [n=74], entecavir [n=77] or tenofovir [n=72]; viral breakthrough occurred in 32% on lamivudine, 2.5% on entecavir, but none on tenofovir; no discussion of ALT flares).
Mandala J, Nanda K, Wang M, De Baetselier I, Deese J, Lombaard J, Owino F, et al. (2014). Liver and renal safety of tenofovir disoproxil fumarate in combination with emtricitabine among African women in a pre-exposure prophylaxis trial. BMC Pharmacol Toxicol. (Among 2058 HIV-positive African women enrolled in a controlled trial of preexposure prophylaxis against HIV who were treated with tenofovir/emtricitabine vs placebo, minor elevations in creatinine and ALT were more frequent in those on antivirals but marked ALT elevations [above 5 times ULN] were rare and occurred in a similar proportion [8 women in both groups]).
Patil R, Ona MA, Papafragkakis H, Carey J, Moshenyat Y, Alhaddad A, Anand S. (2015). Acute liver toxicity due to efavirenz/ emtricitabine/tenofovir. Case Reports Hepatol. (24 year old man with HIV infection developed hepatitis 2 months after starting a regimen of efavirenz with tenofovir and emtricitabine [bilirubin 0.6 mg/dL, ALT 1793 U/L], which resolved after switching from efavirenz to rilpivirine).
Habib G, Nashashibi M. (2015). Tenofovir-induced severe hepatitis in occult hepatitis B reactivation. Dig Liver Dis. (56 year old man with B-cell lymphoma treated with rituximab-CHOP developed reactivation of hepatitis B but did not develop abnormal liver tests until treated with tenofovir, serum ALT rising from normal to 1418 U/L and bilirubin from normal to 18.6 mg/dL, then resolving when he was switched to entecavir).
Gowda C, Newcomb CW, Liu Q, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, et al. (2017). Risk of acute liver injury with antiretroviral therapy by viral hepatitis status. Open Forum Infect Dis. (Among 10,083 patients with HIV followed after initiation of antiretroviral therapy, 206 [2%] developed de novo ALT elevations above 200 U/L but no instances of acute liver failure, elevations being more common among those with hepatitis B or C co-infection).
Kang MK, Park JG. (2018). Tenofovir disoproxil fumarate-induced severe liver injury in a patient with chronic hepatitis B virus infection. Dig Liver Dis. (68 year old woman with cirrhosis due to hepatitis B developed a flare on starting therapy with tenofovir [ALT rising from 62 to 357 U/L, bilirubin 1.69 to 3.63 mg/dL], resolving on switching to entecavir and adefovir).

## OTHER REFERENCE LINKS

1 Recent References on Tenofovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tenofovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tenofovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tenofovir)